# Agents Included in LiverTox by Drug Class

## Drugs by Class:

- ACE Inhibitors
  - See Angiotensin-Converting Enzyme Inhibitors
- Acetaminophen
- Agents of Abuse
  - Amphetamines, Cocaine, Ecstasy (see Amphetamines), Ketamine, Khat, Phencyclidine
- Alkylating Agents
  - Altretamine,Bendamustine, Busulfan, Carmustine, Chlorambucil, Cyclophosphamide, Dacarbazine, Ifosfamide, Lomustine, Lurbinectedin, Mechlorethamine, Melphalan, Procarbazine, Streptozocin, Temozolomide, Thiotepa, Trabectedin
  - Platinum Coordination Complexes
    - Carboplatin, Cisplatin, Oxaliplatin
- Alpha-1 Adrenergic Receptor Antagonists
  - Doxazosin, Prazosin, Terazosin
- Alzheimer Disease Agents
  - Aducanumab, Donanemab, Donepezil, Edaravone, Galantamine, Lecanemab, Memantine, Riluzole, Rivastigmine, Tacrine
- Aminoglycosides
  - Amikacin, Gentamicin, Neomycin, Plazomicin, Streptomycin, Tobramycin
- Amoxicillin-Clavulanate
- Anabolic Steroids
  - Danazol, Fluoxymesterone, Methandienone, Methenolone, Methyltestosterone, Nandrolone, Norethandrolone, Oxandrolone, Oxymetholone, Stanozolol, Testosterone
- Analgesics
  - See Nonsteroidal Antiinflammatory Drugs (NSAIDs)
  - See Opioids, Opioid Antagonists
- Androgenic Steroids
  - See Anabolic Steroids
- Anesthetics, General
  - Barbiturates
    - Amobarbital, Methohexital, Thiopental
  - Halogenated
    - Desflurane, Enflurane, Halothane, Isoflurane, Sevoflurane
  - Miscellaneous
    - Ketamine, Nitrous Oxide, Propofol
- Anesthetics, Local
  - Amides
    - Articaine, Bupivacaine, Lidocaine, Mepivacaine, Prilocaine, Ropivacaine
- Angiotensin-Converting Enzyme Inhibitors
  - Benazepril, Captopril, Enalapril, Fosinopril, Lisinopril, Moexipril, Perindopril, Quinapril, Ramipril, Trandolapril
- Angiotensin II Receptor Antagonists
  - Azilsartan, Candesartan, Eprosartan, Irbesartan, Losartan, Olmesartan, Telmisartan, Valsartan
- Anthelmintic Agents
  - Albendazole, Ivermectin, Mebendazole, Nitazoxanide, Pentamidine, Praziquantel, Pyrantel, Thiabendazole, Triclabendazole
- Anthrax Antitoxins
  - See Antiinfective Agents, Antitoxins
- Antiandrogens
  - Abiraterone, Bicalutamide, Cyproterone, Enzalutamide, Flutamide, Nilutamide
- Antiangina Agents
  - Organic Nitrates
    - Isosorbide Dinitrate, Isosorbide Mononitrate, Nitroglycerin
  - Ranolazine
- Antianxiety Agents
  - See Benzodiazepines
  - See Sedatives and Hypnotics
- Antiarrhythmic Agents
  - Amiodarone, Disopyramide, Dofetilide, Dronedarone, Flecainide, Ivabradine, Mexiletine, Procainamide, Propafenone, Quinidine
- Antiasthmatic Agents
  - Beta-2 Adrenergic Agonists
    - Albuterol, Bitolterol, Formoterol, Metaproterenol, Pirbuterol, Salbutamol, Salmeterol, Terbutaline
  - Leukotriene Receptor Antagonists
    - Montelukast, Zafirlukast
  - Monoclonal Antibodies
    - Benralizumab, Dupilumab, Mepolizumab, Omalizumab, Reslizumab, Tezepelumab
  - Xanthine Derivatives
    - Theophylline
  - Zileuton
- Anticholinergic Agents
  - Aclidinium, Atropine, Homatropine, Darifenacin, Dicyclomine, Fesoterodine, Flavoxate, Glycopyrrolate, Hyoscyamine, Ipratropium, Mepenzolate, Methscopolamine, Oxybutynin, Propantheline, Revefenacin, Scopolamine, Solifenacin, Tiotropium, Tolterodine, Trospium
- Anticoagulants
  - See Antithrombotic Agents
- Anticonvulsants
  - Brivaracetam, Cannabidiol, Carbamazepine, Cenobam[underlined: ate], Clobazam, Clonazepam, Clorazepate, Diazepam, Eslicarbazepine, Ethosuximide, Ezogabine, Felbamate, Fosphenytoin, Gabapentin, Gabapentin Enacarbil, Lacosamide, Lamotrigine, Levetiracetam, Methsuximide, Oxcarbazepine, Perampanel, Phenobarbital, Phenytoin, Pregabalin, Primidone, Rufinamide, Stiripentol, Tiagabine, Topiramate, Valproate, Vigabatrin, Zonisamide
- Antidepressant Agents
  - MAO Inhibitors
    - Isocarboxazid, Phenelzine, Tranylcypromine
  - SNRIs
    - Duloxetine, Levomilnacipran, Venlafaxine
  - SSRIs
    - Citalopram, Escitalopram, Fluoxetine, Fluvoxamine, Paroxetine, Sertraline, Vilazodone, Vortioxetine
  - Tricyclics
    - Amitriptyline, Amoxapine, Clomipramine, Desipramine, Doxepin, Imipramine, Nortriptyline, Protriptyline, Trimipramine
  - Miscellaneous
    - Brexanolone, Bupropion, Esketami[underlined: ne], Flibanserin, Mirtazapine, Nefazodone, Trazodone
- Antidiabetic Agents
  - Alpha-Glucosidase Inhibitors
    - Acarbose, Miglitol
  - Incretin-Based Drugs
    - Dipeptidyl Peptidase-4 (DPP-4) Inhibitors
      - Alogliptin, Linagliptin, Saxagliptin, Sitagliptin
    - Glucagon-Like Peptide-1 (GLP-1) Analogues
      - Albiglutide, Dulaglutide, Exenatide, Liraglutide, Lixisenatide, Semaglutide, Tirzepatide
  - Insulin
  - Metformin
  - Metiglinide Analogues
    - Nateglinide, Repaglinide
  - Pramlintide
  - Sodium Glucose Cotransporter-2 (SGLT2) Inhibitors
    - Bexagliflozin, Canagliflozin, Dapagliflozin, Empagliflozin, Ertugliflozin
  - Sulfonylureas
    - First Generation Sulfonylureas
      - Acetohexamide, Chlorpropamide, Tolazamide, Tolbutamide
    - Second Generation Sulfonylureas
      - Gliclazide, Glimepiride, Glipizide, Glyburide (Glibenclamide)
  - Thiazolidinediones
    - Pioglitazone, Rosiglitazone, Troglitazone
  - Miscellaneous
    - Teplizumab
- Antidotes, Toxicological Emergency
  - Acetylcysteine
  - See also Chelating Agents
  - See also Opioids, Opioid Antagonists
- Antiemetic Agents
  - Anticholinergic Agents
    - Hyoscyamine, Methscopolamine, Scopolamine
  - Antihistamines
    - Cyclizine, Dimenhydrinate, Hydroxyzine, Meclizine, Promethazine
  - Cannabinoid Receptor Agonists
    - Dronabinol, Nabilone, Tetrahydrocannabinol
  - Phenothiazines [See Antipsychotic Agents]
    - Chlorpromazine, Prochlorperazine
  - Serotonin 5-HT3 Receptor Antagonists
    - Alosetron, Dolasetron, Granisetron, Ondansetron, Palonosetron
  - Substance P/Neurokinin 1 Receptor Antagonists
    - Aprepitant, Fosaprepitant, Fosnetupitant, Rolapitant
  - Miscellaneous
    - Amisulpride, Dexamethasone, Metoclopramide, Trimethobenzamide
- Antifungal Agents
  - Amphotericin B, Anidulafungin, Caspofungin, Clotrimazole, Echinocandins, Fluconazole, Flucytosine, Griseofulvin, Ibrexafungerp, Isavuconazonium, Itraconazole, Ketoconazole, Micafungin, Nystatin, Pentamidine, Posaconazole, Terbinafine, Voriconazole
- Antigout Agents
  - Allopurinol, Benzbromarone, Colchicine, Febuxostat, Lesinurad, Pegloticase, Probenecid, Rasburicase
- Antihistamines
  - First Generation
    - Brompheniramine, Carbinoxamine, Chlorcyclizine, Chlorpheniramine, Clemastine, Cyclizine, Cyproheptadine, Dexbrompheniramine, Dexchlorpheniramine, Dimenhydrinate, Diphenhydramine, Doxylamine, Hydroxyzine, Meclizine, Phenyltoloxamine, Promethazine, Triprolidine
  - Second Generation
    - Acrivastine, Cetirizine, Fexofenadine, Levocetirizine, Loratadine, Desloratadine
- Antihypertensive Agents
  - Aliskiren, Clonidine, Guanfacine, Hydralazine, Methyldopa, Minoxidil, Sodium Nitroprusside, Reserpine
  - Alpha-1 Adrenergic Receptor Antagonists
    - Doxazosin, Prazosin, Terazosin
  - Sacubitril-Valsartan [Heart Failure Agent]
  - See also Angiotensin-Converting Enzyme Inhibitors, Angiotensin II Receptor Antagonists, Beta-Adrenergic Receptor Antagonists, Calcium Channel Blockers, Diuretics
- Antiinfective Agents
  - Antibacterial Agents, Classes
    - Aminoglycosides, Carbapenems, Cephalosporins, Fluoroquinolones, Glycopeptides, Macrolide Antibiotics, Penicillins, Sulfonamides, Tetracyclines
  - Antibacterial Agents, Miscellaneous
    - Aztreonam, Benznidazole, Chloramphenicol, Clindamycin, Daptomycin, Fosfomycin, Lefamulin, Linezolid, Methenamine, Metronidazole, Nitrofurantoin, Quinupristin-Dalfopristin, Secnidazole, Tedizolid, Tinidazole, Vancomycin
  - Antifungal Agents
  - Antihelmintic Agents
  - Antimalarial Agents
  - Antitoxins
    - Bezlotoxumab, Obiltoxaximab, Raxibacumab
  - Antituberculosis Agents
  - Antiviral Agents
  - Leishmaniasis Agents
    - Miltefosine
  - Leprosy Agents
    - Clofazimine, Dapsone, Rifampin
- Antilipemic Agents
  - Bile Acid Resins/Sequestrants
    - Cholestyramine, Colesevelam, Colestipol
  - Fibrates
    - Clofibrate, Fenofibrate, Gemfibrozil
  - Monoclonal Antibodies
    - Anti-PCSK9
      - Alirocumab, Evolocumab
    - Anti-ANGPTL3
      - Evinacumab
  - Niacin (Nicotinic Acid)
  - Omega-3 Fatty Acids,
    - Icosapent Ethyl, Omega-3 Acid Ethyl Esters, Omega-3 Carboxylic Acids
  - Statins
    - Atorvastatin, Fluvastatin, Lovastatin, Pitavastatin, Pravastatin, Rosuvastatin, Simvastatin
  - Miscellaneous
    - Bempedoic Acid, Ezetimibe, Lomitapide, Mipomersen, Resmetirom
- Antimalarial Agents
  - Amodiaquine, Artemisinin, Atovaquone, Chloroquine, Mefloquine, Mepacrine, Primaquine, Proguanil, Quinine, Tafenoquine
- Anti-Migraine
  - See Migraine Headache Agents
- Antineoplastic Agents
  - Alkylating Agents
    - Altretamine, Bendamustine, Busulfan, Carmustine, Chlorambucil, Cyclophosphamide, Dacarbazine, Ifosfamide, Lomustine, Lurbinectedin, Mechlorethamine, Melphalan, Procarbazine, Streptozocin, Temozolomide, Thiotepa, Trabectedin
    - Platinum Coordination Complexes
      - Carboplatin, Cisplatin, Oxaliplatin
  - Antibiotics, Cytotoxic
    - Bleomycin, Dactinomycin, Daunorubicin, Doxorubicin, Epirubicin, Idarubicin, Mitomycin, Mitoxantrone, Plicamycin [Mithramycin], Valrubicin
  - Antimetabolites
    - Antifolates
      - Methotrexate, Pemetrexed, Pralatrexate, Trimetrexate
    - Purine Analogues
      - Azathioprine, Cladribine, Clofarabine, Fludarabine, Mercaptopurine, Nelarabine, Pentostatin, Thioguanine
    - Pyrimidine Analogues
      - Azacitidine, Capecitabine, Cytarabine, Decitabine, Floxuridine, Fluorouracil, Gemcitabine, Trifluridine/Tipracil
  - Biologic Response Modifiers
    - Aldesleukin (IL-2), Denileukin Diftitox, Interferon gamma
  - Histone Deacetylase Inhibitors
    - Belinostat, Panobinostat, Romidepsin, Vorinostat
  - Hormonal Agents
    - Antiandrogens
      - Abiraterone, Apalutamide, Bicalutamide, Cyproterone, Enzalutamide, Flutamide, Nilutamide
    - Antiestrogens (including Aromatase Inhibitors)
      - Anastrozole, Exemestane, Letrozole
      - Selective Estrogen Receptor Degraders
        - Elacestrant, Fulvestrant
      - Selective Estrogen Receptor Modulators
        - Raloxifene, Tamoxifen, Toremifene
    - Gonadotropin Releasing Hormone Analogues
      - Degarelix, Goserelin, Histrelin, Leuprolide, Relugolix, Triptorelin
    - Peptide Hormones
      - Lanreotide, Octreotide, Pasireotide
  - Monoclonal Antibodies
    - Alemtuzumab, Amivantamab, Atezolizumab, Avelumab, Belantamab, Bevacizumab, Blinatumomab, Brentuximab, Cemiplimab, Cetuximab, Daratumumab, Dinutuximab, Dostarlimab, Durvalumab, Elotuzumab, Enfortumab, Gemtuzumab, Inotuzumab Ozogamicin, Ipilimumab, Margetuximab, Mogamulizumab, Moxetumomab Pasudotox, Naxitamab, Necitumumab, Nivolumab, Ofatumumab, Olaratumab, Panitumumab, Pembrolizumab, Pertuzumab, Polatuzumab Vedotin, Ramucirumab, Rituximab, Sacituzumab Govitecan, Tafasitamab, Teclistamab, Tisotumab Vedotin, Tositumomab, Trastuzumab, Trastuzumab Deruxtecam, Trastuzumab Emtansine, Tremelimumab
  - Protein Kinase Inhibitors
    - Abemaciclib, Acalabrutinib, Adagrasib, Afatinib, Alectinib, Alpelisib, Asciminib, Avapritinib, Axitinib, Binimetinib, Bortezomib, Bosutinib, Brigatinib, Cabozantinib, Capivasertib, Capmatinib, Carfilzomib, Ceritinib, Cobimetinib, Copanlisib, Crizotinib, Dabrafenib, Dacomitinib, Dasatinib, Duvelisib, Enasidenib, Encorafenib, Ensartinib, Entrectinib, Erdafitinib, Erlotinib, Fedratinib, Fruquintinib, Futibatinib, Gefitinib, Gilteritinib, Glasdegib, Ibrutinib, Idelalisib, Imatinib, Inavolisib, Infigratinib, Ivosidenib, Ixazomib, Lapatinib, Larotrectinib, Lazertinib, Lenvatinib, Lorlatinib, Midostaurin, Mobocertinib, Momelotinib, Neratinib, Nilotinib, Niraparib, Olaparib, Olutasidenib, Osimertinib, Pacritinib, Palbociclib, Pazopanib, Pemigatinib, Pexidartinib, Pirtobrutinib, Ponatinib, Pralsetinib, Quizartinib, Regorafenib, Repotrectinib, Revumenib, Ribociclib, Ripretinib, Rucaparib, Ruxolitinib, Selpercatinib, Selumetinib, Sonidegib, Sorafenib, Sotorasib, Sunitinib, Talazoparib, Tepotinib, Tivozanib, Tovorafenib, Trametinib, Trilaciblib, Tucatinib, Umbralisib, Vandetanib, Vemurafenib, Vismodegib, Zanubrutinib
  - Taxanes
    - Cabazitaxel, Docetaxel, Paclitaxel
  - Topoisomerase Inhibitors
    - Etoposide, Irinotecan, Teniposide, Topotecan
    - Tyrosine Kinase Receptor Inhibitors
  - Vinca Alkaloids
    - Vinblastine, Vincristine, Vinorelbine
  - Miscellaneous
    - Asparaginase (Pegaspargase), Belzutifan, Bexarotene, Cedazuridine, Eribulin, Everolimus, Hydroxyurea, Ixabepilone, Lenalidomide, Mitotane, Omacetaxine, Pomalidomide, Selinexor, Tagraxofusp, Tazemetostat, Tebentafusp, Telotristat, Temsirolimus, Thalidomide, Venetoclax
- Antiparkinson Agents
  - See Parkinson Disease Agents
- Antiplatelet Agents
  - See Antithrombotic Agents
- Antipsychotic Agents
  - First Generation
    - Phenothiazines
      - Chlorpromazine, Fluphenazine, Perphenazine, Prochlorperazine, Thioridazine, Trifluoperazine
    - Other
      - Haloperidol, Lithium, Loxapine, Molindone, Pimozide
  - Second Generation (Atypicals)
    - Aripiprazole, Asenapine, Brexpiprazole, Cariprazine, Clozapine, Iloperidone, Lumateperone, Lurasidone, Olanzapine, Paliperidone, Pimavanserin, Quetiapine, Risperidone, Ziprasidone
- Antirheumatic Agents
  - Gold Preparations
    - Auranofin, Gold Salts, Gold Sodium Thiomalate
  - Interleukin Receptor Antagonists
    - Anakinira, Canakinumab, Rilonacept, Sarilumab, Tocilizumab
  - Major Immunosuppressive Agents
    - Cyclosporine, Mycophenylate, Sirolimus, Tacrolimus
  - Monoclonal Antibodies
    - [underlined: Adalimumab], Canakinumab, [underlined: Certolizumab], Golimumab, Infliximab, Rituximab, Sarilumab, Tocilizumab, Ustekinumab
  - Thiopurines
    - Azathioprine, Mercaptopurine, Thioguanine
  - Tumor Necrosis Factor Antagonists
    - Adalimumab, Certolizumab, Etanercept, Golimumab, Infliximab
  - Tyrosine (Janus) Kinase Inhibitors
    - Baricitinib, Tofacitinib, Upadacitinib
  - Miscellaneous
    - Abatacept, Flavocoxid, Hydroxychloroquine, Leflunomide, Methotrexate, Penicillamine
- Antithrombotic Agents
  - Anticoagulants
    - Dabigatran Etexilate, Desirudin
    - Apixaban, Betrixaban, Edoxaban, Fondaparinux, Rivaroxaban
    - Heparins
      - Heparin, Dalteparin, Enoxaparin, Tinzaparin
    - Warfarin
  - Antiplatelet Agents
    - Aspirin, Cangrelor, Clopidogrel, Dipyridamole, Prasugrel, Ticagrelor, Ticlopidine, Vorapaxar
  - Miscellaneous
    - Anagrelide, Defibrotide, Drotrecogin alfa
- Antithyroid Agents
  - See Thyroid and Antithyroid Agents
- Antitoxins
  - Bezlotoxumab, Obiltoxaximab, Raxibacumab
- Antituberculosis Agents
  - Bedaquiline, Capreomycin, Cycloserine, Ethambutol, Ethionamide, Isoniazid, Pretomanid, Pyrazinamide, Rifabutin, Rifampin, Rifapentine, Streptomycin
- Antiulcer Agents
  - Proton Pump Inhibitors
    - Dexlansoprazole, Esomeprazole, Lansoprazole, Omeprazole, Pantoprazole, Rabeprazole
  - Selective Histamine Type 2 Receptor Antagonists/Blockers
    - Cimetidine, Famotidine, Nizatidine, Ranitidine
- Antiviral Agents
  - Attachment Inhibitors (HIV)
    - Fostemsavir
  - Capsid Inhibitor
    - Lenacapavir
  - Fusion Inhibitors (HIV)
    - Enfuvirtide, Maraviroc
  - Integrase Inhibitors (HIV)
    - Bictegravir, Cabotegravir, Dolutegravir, Elvitegravir, Raltegravir
  - Monoclonal Antibodies
    - Ibalizumab
  - Neuraminidase and Endonuclease Inhibitors (Influenza)
    - Baloxavir, Oseltamivir, Peramivir, Zanamivir
  - Nonnucleoside Reverse Transcriptase Inhibitors
    - Delavirdine, Doravirine, Efavirenz, Etravirine, Nevirapine, Rilpivirine
  - Nucleoside Analogues
    - Abacavir, Acyclovir, Adefovir, Brincidofovir, Cidofovir, Didanosine, Emtricitabine, Entecavir, Famciclovir, Ganciclovir/Valganciclovir, Lamivudine, Remdesivir, Sofosbuvir, Stavudine, Telbivudine, Tenofovir, Valacyclovir, Zidovudine
  - Protease Inhibitors (Hepatitis C/HCV)
    - Asunaprevir, Boceprevir, Glecaprevir, Grazoprevir, Paritaprevir, Simeprevir, Telaprevir
    - See also Hepatitis C (HCV) Drugs
  - Protease Inhibitors (HIV)
    - Amprenavir, Atazanavir, Darunavir, Fosamprenavir, Indinavir, Lopinavir, Nelfinavir, Ritonavir, Saquinavir, Tipranavir
  - Miscellaneous
    - Acyclovir, Alpha Interferon, Amantadine, Cidofovir, Famciclovir, Foscarnet, Ganciclovir, Letermovir, Maribavir, Peginterferon, Ribavirin, Rimantadine, Tecovirimat, Valacyclovir, Valganciclovir
- Attention Deficit/Hyperactivity Disorder (ADHD) Agents
  - Stimulants
    - Amphetamines, Methylphenidate
  - Nonstimulants
    - Atomoxetine, Clonidine, Guanfacine, Viloxazine
- Aztreonam
- Benign Prostatic Hypertrophy Agents
  - Alpha-1 Adrenergic Receptor Antagonists
    - Alfuzosin, Silodosin, Tamsulosin
  - 5-Alpha Reductase Inhibitors
    - Dutasteride, Finasteride
- Benzodiazepines
  - Alprazolam, Chlordiazepoxide, Clobazam, Clonazepam, Clorazepate, Diazepam (Intravenous), Diazepam (Oral), Estazolam, Flurazepam, Lorazepam, Midazolam, Oxazepam, Quazepam, Remimazolam, Temazepam, Triazolam
- Beta-Adrenergic Receptor Antagonists
  - Acebutolol, Atenolol, Betaxolol, Bisoprolol, Carvedilol, Esmolol, Labetalol, Metoprolol, Nadolol, Nebivolol, Penbutolol, Pindolol, Propranolol, Sotalol, Timolol
- Bisphosphonates
  - Alendronate, Etidronate, Ibandronate, Pamidronate, Risedronate, Zoledronic Acid
- Caffeine
  - See Energy Drinks
- Calcium Channel Blockers
  - Amlodipine, Diltiazem, Felodipine, Isradipine, Nicardipine, Nifedipine, Nimodipine, Nisoldipine, Verapamil
- Carbapenems
  - Doripenem, Ertapenem, Imipenem-Cilastatin, Meropenem
- Cardiac Glycosides
  - Digitalis, Digoxin
- Central Nervous System (CNS) Stimulants
  - Amphetamines, Atomoxetine, Cocaine, Methylphenidate, Modafinil and Armodafinil (Isomers), Oxybate, Pitolisant, Solriamfetol
- Cephalosporins
  - Cefaclor, Cefadroxil, Cefazolin, Cefdinir, Cefditoren, Cefepime, Cefixime, Cefoperazone, Cefotaxime, Cefoxitin, Cefpodoxime, Cefprozil, Ceftazidime, Ceftibuten, Ceftizoxime, Ceftriaxone, Cefuroxime, Cephalexin, Cephradine
- Chelating Agents
  - Arsenic Chelators
    - Dimercaprol
  - Copper Chelators (for Wilson Disease)
    - Dimercaprol, Penicillamine, Trientine, Zinc
  - Iron Chelators
    - Deferasirox, Deferiprone, Deferoxamine
  - Lead Chelators
    - Dimercaprol, [EDTA; not in LiverTox], Succimer
  - Mercury Chelators
    - Dimercaprol
- Cholesterol Lowering Agents
  - See Antilipemic Agents
- Chronic Obstructive Pulmonary Disease Agents
  - See Pulmonary Disease Agents
- Corticosteroids
  - Budesonide, Cortisol, Cortisone, Dexamethasone, Hydrocortisone, Methylprednisolone, Prednisolone, Prednisone, Triamcinolone
- COVID-19 Drugs
  - Azithromycin, Baricitinib, Chloroquine, Corticosteroids, Dexamethasone, [underlined: Favipiravir], Fluvoxamine, Hydroxychloroquine, Ivermectin, Molnupiravir, Paxlovid, Remdesivir, Ruxolitinib, Sarilumab, Tocilizumab, Tofacitinib
- COVID-19 Monoclonal Antibodies [Monoclonal Antibodies to SARS-CoV-2]
  - Bamlanivimab, Casirivimab, Etesevimab, Imdevimab, Sotrovimab
- COVID-19 Vaccines
- Dermatologic Agents
  - Atopic Dermatitis
    - Abrocitinib, Dupilumab, Tralokinumab
  - Psoriasis Agents
    - Acitretin, Alefacept, Apremilast, Cyclosporine, Methotrexate, Psoralen (Methoxsalen)
    - Monoclonal Antibodies
      - IL-17A Antagonists
        - Brodalumab, Ixekizumab, Secukinumab
      - Tumor Necrosis Factor Antagonists
        - Adalimumab, Certolizumab, Etanercept, Golimumab, Infliximab
      - Other
        - Deucravacitinib, Deuruxolitinib, Efalizumab, Guselkumab, Risankizumab, Tildrakizumab, Ustekinumab
- Disulfiram
- Diuretics
  - Carbonic Anhydrase Inhibitors
    - Acetazolamide, Methazolamide
  - Loop Diuretics
    - Bumetanide, Ethacrynic Acid, Furosemide, Torsemide
  - Potassium-Sparing Diuretics
    - Amiloride, Eplerenone, Spironolactone, Triamterene
  - Thiazide Diuretics
    - Bendroflumethiazide, Chlorothiazide, Chlorthalidone, Hydrochlorothiazide, Indapamide, Metolazone, Polythiazide
  - Vasopressin Antagonists
    - Tolvaptan Triamterene
  - Miscellaneous
    - Finerenone
- Drugs of Abuse
  - See Agents of Abuse
- Endocrine Disease Agents
  - Osilodrostat
- Energy Drinks
- Estrogens and Oral Contraceptives
  - See Obstetrical and Gynecological Agents
- Fibromyalgia Agents
  - Milnacipran
- Fluoroquinolones
  - Ciprofloxacin, Delafloxacin, Gemifloxacin, Levofloxacin, Moxifloxacin, Norfloxacin, Ofloxacin
- Gastrointestinal Agents
  - Antidiarrheals
    - Absorbents and Protectants
      - Bismuth, Kaolin, Pectin
    - Antimotility Agents
      - Difenoxin, Diphenoxylate, Loperamide
    - Bile Acid Resins/Sequestrants [See Antilipemic Agents]
      - Cholestyramine, Colesevelam, Colestipol
    - Bulk-Forming Agents
      - Methylcellulose
    - Travelers' Diarrhea
      - Rifamycin, Rifaximin
    - Miscellaneous
      - Crofelemer, Octreotide, Somatostatin
  - Antiemetic Agents
    - Anticholinergic Agents
      - Hyoscyamine, Methscopolamine, Scopolamine
    - Antihistamines
      - Cyclizine, Dimenhydrinate, Hydroxyzine, Meclizine, Promethazine
    - Cannabinoid Receptor Agonists
      - Dronabinol, Nabilone, Tetrahydrocannabinol
    - Phenothiazines [See Antipsychotic Agents]
      - Chlorpromazine, Prochlorperazine
    - Serotonin 5-HT3 Receptor Antagonists
      - Alosetron, Dolasetron, Granisetron, Ondansetron, Palonosetron
    - Substance P/Neurokinin 1 Receptor Antagonists
      - Aprepitant, Fosaprepitant, Fosnetupitant, Rolapitant
    - Miscellaneous
      - Amisulpride, Dexamethasone, Metoclopramide, Trimethobenzamide
  - Acid-Peptic Disease Agents/Antiulcer Agents
    - Proton Pump Inhibitors
      - Dexlansoprazole, Esomeprazole, Lansoprazole, Omeprazole, Pantoprazole, Rabeprazole
    - Selective Histamine Type 2 Receptor Antagonists/Blockers
      - Cimetidine, Famotidine, Nizatidine, Ranitidine
  - Bile Acids
    - Chenodiol (Chenodeoxycholic Acid), Cholic Acid, Obeticholic Acid, Ursodiol (Ursodeoxycholic Acid)
  - Cathartics and Laxatives
    - Anthraquinones
      - Cascara Sagrada, Senna
    - Bulk-Forming
      - Fiber, Bran, Methylcellulose
    - Opioid Antagonists
      - Naloxego, Naldemedine
    - Saline
      - Magnesium Sulfate
    - Stimulant
      - Bisacodyl, Castor Oil
    - Stool Softeners
      - Docusate, Lactulose
    - Miscellaneous
      - Plecanatide, Prucalopride
  - Inflammatory Bowel Disease Agents
    - 5-Aminosalicyclic Acid (5-ASA) Derivatives
      - Balsalazide, Mesalamine, Olsalazine, Sulfasalazine
    - Immunosuppressive Agents
      - Azathioprine, Mercaptopurine, Methotrexate
    - Tumor Necrosis Factor Antagonists
      - Adalimumab, Certolizumab, Golimumab, Infliximab
    - Miscellaneous
      - Metronidazole, Natalizumab, Vedolizumab
  - Irritable Bowel Syndrome Agents
    - Antimuscarinics/Antispasmodics [See Anticholinergic Agents]
      - Dicyclomine, Glycopyrrolate, Hyoscyamine, Methscopolamine
    - Prokinetic Agents [See Serotonin 5-HT4 Receptor Agonists]
      - Alosetron, Cisapride, Domperidone, Linaclotide, Lubiprostone, Metoclopramide, Plecanatide, Prucalopride, Tegaserod
    - Other
      - Eluxadoline, Tenapanor
- Genetic Disorder Agents
  - Achondroplasia
    - Vosoritide
  - Activated PI3K-delta Syndrome
    - Leniolisib
  - Adrenal Hyperplasia Agents
    - Crinecerfont
  - siRNA and Antisense Agents
    - Acute Hepatic Porphyria Agents
      - Givosiran
    - Amyloidosis Agents
      - Acoramidis, Eplontersen, Inotersen, Patisiran, Tafamidis, Vutrisiran
    - Antilipemic Agents
      - Inclisiran
    - Duchenne Muscular Dystrophy Agents
      - Casimersen, Eteplirsen, Golodirsen, Viltolarsen
    - Hyperoxaluria Type 1 Agents
      - Lumasiran, Nedosiran
  - Cystic Fibrosis Agents
    - Ivacaftor, Lumacaftor, Tezacaftor
  - Cystinosis Agents
    - Cysteamine
  - Enzyme Replacement Therapy
    - Gaucher Disease Agents
      - Glucocerebrosidase (Enzyme Replacement Therapy)
        - Imiglucerase, Taliglucerase alfa, Velaglucerase alfa
      - Glucosylceramide Synthase Inhibitors (Substrate Restriction Therapy)
        - Eliglustat, Miglustat
    - Lysosomal Acid Lipase Deficiency Agents
      - Sebelipase alfa
    - Miscellaneous
    - Agalsidase beta, Alglucosidase alfa, Alpha1-Proteinase inhibitor, Elosulfase alfa, Galsulfase, Idursulfase, Laronidase, Pegademase
  - Erythropoietic Protoporphyria Agents
    - Afamelanotide
  - Fabry Disease Agents
    - Migalastat
  - Friedreich Ataxia Agents
    - Omaveloxolone
  - Hereditary Angioedema Agents
    - Berinert, Berotralstat, Cinryze, Danazol, Ecallantide, Haegarda, Icatibant, Lanadelumab, Ruconest
  - Homocystinuria Agents
    - Betaine
  - Huntington Disease Agents (for Chorea)
    - Vesicular Monoamine Transporter 2 (VMAT2) Inhibitors
      - Deutetrabenazine, Tetrabenazine, Valbenazine
  - Monoclonal Antibodies
    - Burosumab
  - Sickle Cell Disease Agents
    - Crizanlizumab, Hydroxyurea, L-Glutamine, Voxelotor
  - Spinal Muscular Atrophy Agents
    - Risdiplam, Osmogene Abeparvovec
  - Tyrosinemia Agents
    - Nitisinone
  - Urea Cycle Disorder Agents
    - Carglumic Acid, Lactulose, Phenylbutyrate, Rifaximin, Sodium Benzoate
- Glycopeptide Antibiotics
  - Dalbavancin, Oritavancin, Telavancin, Vancomycin
- Hematologic Agents Agents
  - Myelodysplastic Syndrome Agents
    - Imetelstat
  - Paroxysmal Nocturnal Hemoglobinuria
    - Pegcetacoplan
  - See Antithrombotic Agents
  - See Hematologic Growth Factors
  - See Monoclonal Antibodies
  - See Genetic Disorder Agents, Sickle Cell Disease Agents
- Hematologic Growth Factors
  - Colony Stimulating Factors
    - Granulocyte Colony Stimulating Factors
      - Filgrastim, Pegfilgrastim
    - Granulocyte-Macrophage Colony Stimulating Factors
      - Sargramostim
  - Erythropoiesis Stimulating Agents
    - Daprodustat, Epoetin, Darbepoetin, Peginesatide
  - Thrombopoietin Receptor Agonists and Thrombopoiesis Stimulators
    - Avatrombopag, Eltrombopag, Fostamatinib, Lusutrombopag, Romiplostim, Oprelvekin (IL-11)
  - Miscellaneous
    - Luspatercept
- Hepatitis C (HCV) Agents
  - Interferon Based Therapies
    - Interferon A and Peginterferon, Interferon B, Ribavirin
  - NS5A Inhibitors
    - Daclatasvir, Elbasvir, Ledipasvir, Ombitasvir, Pibrentasvir, Velpatasvir
  - NS5B (Polymerase) Inhibitors
    - Dasabuvir, Sofosbuvir
  - HCV Protease Inhibitors
    - Asunaprevir, Boceprevir, Glecaprevir, Grazoprevir, Paritaprevir, Simeprevir, Telaprevir, Voxilaprevir
  - Combination Therapies
    - Epclusa, Harvoni, Mavyret, Technive, Viekira Pak, Vosevi, Zepatier
- Herbal and Dietary Supplements
  - Aloe Vera, Alpha Lipoic Acid, Apoaequorin, Areca Nut, Arnica Montana, Ashwagandha, Astragalus, Bacopa, Bee Products, Berberine, Bilberry, Bitter Melon, Black Cohosh, Black Cumin, Boswellia, Bromelain, Buchu, Butterbur, Cascara, Cat's Claw, Centella Asiatica, Chamomile, Chaparral, Chaste Tree, Chondroitin, Comfrey, Cranberry, Crofelemer, Dihydromyricetin, Dragon’s Blood, Echinacea, Ephedra, Eugenol, Fenugreek, Flavocoxid, Garcinia cambogia, Germander, Ginger, Ginkgo, Ginseng, Glucosamine, Grape Seed, Greater Celandine, Green Tea, Guarana, Gymnema, Hawthorn, Hoodia, Hops, Horny Goat Weed, Horse Chestnut, Horsetail, Hyssop, Kava Kava, Kelp, Khat, Kratom, Lavender, Lemon Balm, Licorice, Lingzhi, Reishi, Lion’s Mane, Maca, Margosa Oil, Melatonin, Milk Thistle, Mistletoe, Moringa, Noni, Nux Vomica, Oregano, Passionflower, Pennyroyal Oil, Quercetin, Red Yeast Rice, Resveratrol, Royal Jelly, Saw Palmetto, Senna, Skullcap, Slippery Elm, Spirulina, St. John's Wort, Stinging Nettle, Tara Flour, Tinospora, Tongkat Ali, Tribulus, Turmeric, Usnic Acid, Uva Ursi, Valerian, Yerba Mate, Yohimbine
  - Chinese and Other Asian Herbal Medicines
    - Ba Jiao Lian, Bol Gol Zhee, Chi R Yun, Jin Bu Huan, Ma Huang [underlined: [Ephedra]], Polygonum Multiflorum, Sho Saiko To and Dai Saiko To, Shou Wu Pian
  - Multi-Ingredient Nutritional Supplements
    - Herbalife, Hydroxycut, Move Free, OxyELITE Pro, SLIMQUICK
  - See also Nutritional Supplements
- Hormonal Agents
  - Growth Hormone Releasing Hormone (GHRH)
    - Tesamorelin
  - Insulin
  - Somatostatin Analogues
    - Lanreotide, Octreotide, Pasireotide
  - See also Anabolic Steroids
  - See also Antineoplastic Agents
  - See also Corticosteroids
  - See also Obstetrical and Gynecological Agents
  - See also Osteoporosis Agents
  - See also Thyroid Agents
- Human Growth Hormone Deficiency Agents
  - Somapacitan
- Hypoglycemic Agents
  - See Antidiabetic Agents
- Ileal Bile Acid Transporter (IBAT) Inhibitors
  - Maralixibat
  - Odevixibat
- Immunomodulatory Agents
  - Efalizumab, Satralizumab
- Immunosuppressive Agents
  - Avacopan, Axatilimab, Belimumab, Siltuximab, Voclosporin
- Infertility Agents
  - See Obstetrical and Gynecological Agents
- Influenza Agents
  - Amantadine, Baloxavir, Oseltamivir, Peramivir, Rimantadine, Zanamivir
- Insomnia Agents
  - See Sedatives and Hypnotics
- Intermittent Claudication Agents
  - Cilostazol, Pentoxifylline
- Leishmaniasis Agents
  - Miltefosine
- Leprosy Agents
  - Clofazimine, Dapsone, Rifampin
- Lincosamides
  - Clindamycin, Lincomycin
- Linezolid
- Lipid-Lowering Agents
  - See Antilipemic Agents
- Liver Disease Agents
  - Elafibranor, Obeticholic Acid, Resmetirom, Seladelpar, Ursodiol
- Lysosomal Acid Lipase Deficiency Agents
  - See Enzyme Replacement Therapy
- Macrolide Antibiotics
  - Azithromycin, Clarithromycin, Erythromycin, Fidaxomicin, Telithromycin
- Macular Degeneration Agents
  - Aflibercept, Avacincaptad pegol, Bevacizumab, Brolucizumab, Faricimab, Pegaptanib, Pegcetacoplan, Ranibizumab
- Methotrexate
- Metronidazole
- Migraine Headache Agents
  - Ergot Alkaloids
    - Ergotamine, Dihydroergotamine
  - Monoclonal Antibodies
    - Eptinezumab, Erenumab, Fremanezumab, Galcanezumab
  - [underlined: Small Molecule CGRP Receptor Antagonists]
    - Atogepant, Rimegepant, Ubrogepant, Zavegepant
  - Triptans
    - Almotriptan, Eletriptan, Frovatriptan, Naratriptan, Rizatriptan, Sumatriptan, Zolmitriptan
  - Miscellaneous
    - Lasmiditan
- Monoclonal Antibodies
  - Alzheimer Disease Agents
    - Aducanumab, Donanemab, Lecanemab
  - Antiasthmatic Agents
    - Benralizumab, Dupilumab, Mepolizumab, Omalizumab, Reslizumab, Tezepelumab
  - Antidiabetic Agents
    - Teplizumab
  - Antiinfective Agents
    - Antitoxins
      - Bezlotoxumab, Obiltoxaximab, Raxibacumab
  - Antilipemic Agents, Anti-PCSK9
    - Alirocumab, Evinacumab (Anti-ANGPTL3), Evolocumab
  - Antineoplastic Agents
    - Alemtuzumab, Amivantamab, Atezolizumab, Avelumab, Belantamab, Bevacizumab, Blinatumomab, Brentuximab, Cemiplimab, Cetuximab, Daratumumab, Dinutuximab, Dostarlimab, Durvalumab, Elotuzumab, Enfortumab, Gemtuzumab, Inotuzumab Ozogamicin, Ipilimumab, Margetuximab, Mogamulizumab, Moxetumomab Pasudotox, Naxitamab, Necitumumab, Nivolumab, Ofatumumab, Olaratumab, Panitumumab, Pembrolizumab, Pertuzumab, Polatuzumab Vedotin, Ramucirumab, Rituximab, Sacituzumab Govitecan, Tafasitamab, Teclistamab, Tisotumab Vedotin, Tositumomab, Trastuzumab, Trastuzumab Deruxtecam, Trastuzumab Emtansine, Tremelimumab
  - Antirheumatic Agents
    - Adalimumab, Canakinumab, Certolizumab, Golimumab, Infliximab, Rituximab, Sarilumab, Tocilizumab, Ustekinumab
  - Antithyroid Agents
    - Teprotumumab (for Graves ophthalmopathy)
  - Antiviral Agents
    - Ibalizumab
  - Atopic Dermatitis Agents
    - Dupilumab, Tralokinumab
  - COVID-19 Agents
    - Bamlanivimab, Casirivimab, Etesevimab, Imdevimab, Sotrovimab
  - Ebolavirus Agents
    - REGN-EB3 – Atoltivimab, Maftivimab, Odesivimab
  - Genetic Disorder Agents
    - Burosumab
  - Hematologic Agents
    - Caplacizumab, Eculizumab, Emapalumab, Emicizumab, Lanadelumab, Ravulizumab
  - Immunomodulatory/Immunosuppressive Agents
    - Anifrolumab, Axatilimab, Belimumab, Efalizumab, Satralizumab, Siltuximab
  - Inflammatory Bowel Disease Agents
    - Adalimumab, Certolizumab, Golimumab, Infliximab, Vedolizumab
  - Macular Degeneration Agents
    - Bevacizumab, Brolucizumab, Faricimab, Ranibizumab
  - Migraine Headache Agents
    - Eptinezumab, Erenumab, Fremanezumab, Galcanezumab
  - Multiple Myeloma Agents
    - Isatuximab
  - Multiple Sclerosis Agents
    - Alemtuzumab, Natalizumab, Ocrelizumab, Ublituximab
  - Neurological Disease Agents
    - Inebilizumab
  - Osteoporosis Agents
    - Denosumab, Romosozumab
  - Psoriasis Agents
    - Adalimumab, Brodalumab, Certolizumab, Efalizumab, Etanercept, Golimumab, Guselkumab, Infliximab, Ixekizumab, Risankizumab, Secukinumab, Tildrakizumab, Ustekinumab
  - Transplant Agents
    - Alemtuzumab, Basiliximab, Daclizumab, Muromonab
- Multiple Sclerosis Agents
  - Alemtuzumab, Dalfampridine, Dimethyl Fumarate, Diroximel Fumarate, Fingolimod, Glatiramer Acetate, Interferon Beta, Mitoxantrone, Monomethyl Fumarate, Natalizumab, Ocrelizumab, Ozanimod, Ponesimod, Siponimod, Teriflunomide, Ublituximab
- Muscle Relaxants
  - Baclofen, Carisoprodol, Chlorzoxazone, Cyclobenzaprine, Dantrolene, Metaxalone, Methocarbamol, Orphenadrine, Quinine, Tizanidine
- Myasthenia Agents
  - Amifampridine
  - Anticholinesterase Inhibitors
    - Neostigmine, Pyridostigmine
  - Efgartigimod alfa, alfa/Hyaluronidase
- Narcotic Antagonists
  - See Opioids, Opioid Antagonists
- Narcotics
  - See Opioids, Opioid Antagonists
- Nitrofurantoin
- Nonsteroidal Antiinflammatory Drugs (NSAIDs)
  - Acetaminophen, Celecoxib, Diclofenac, Diflunisal, Etodolac, Fenoprofen, Flurbiprofen, Ibuprofen, Indomethacin, Ketoprofen, Ketorolac, Mefenamic Acid, Meloxicam, Metamizole, Nabumetone, Naproxen, Nimesulide, Oxaprozin, Phenylbutazone, Piroxicam, Rofecoxib, Sulindac, Tolmetin, Suzetrigine
- Nutritional Supplements
  - Chondroitin, Coenzyme Q10, Docosahexaenoic Acid, Eicosapentaenoic Acid, Glucosamine, alpha-Linolenic Acid, Omega-3 Fatty Acids, Triheptanoin
- Obstetrical and Gynecological Agents
  - Emergency Contraceptive Agents
    - Levonorgestrel, Ulipristal
  - Endometriosis and Menstrual Conditions
    - Gonadotropin Releasing Hormone Antagonists
      - Elagolix
  - Estrogens and Oral Contraceptives
    - Selective Estrogen Receptor Modulators
      - Bazedoxifene, Ospemifene, Raloxifene
  - Infertility Agents
    - Antiestrogens
      - Clomiphene, Letrozole, Tamoxifen
    - Gonadotropins
      - Chorionic Gonadotropin, Follicle Stimulating Hormone, Luteinizing Hormone, Human Gonadotropin Releasing Hormone
  - Menopausal Symptom Agents
    - Fezolinetant
  - Pregnancy Termination Agents
    - Mifepristone
  - Progesterone and the Progestins
- Opioids, Opioid Antagonists
  - Full and Partial Agonists
    - Alfentanil, Butorphanol, Codeine, Diphenoxylate, Fentanyl, Heroin, Hydrocodone, Hydromorphone, Levorphanol, Loperamide, Meperidine, Methadone, Morphine, Oliceridine, Opium, Oxycodone, Oxymorphone, Pentazocine, Remifentanil, Sufentanil, Tramadol
  - Opioid Antagonists
    - Naldemedine, Nalmefene, Naloxegol, Naloxone, Naltrexone
- Osteoporosis Agents
  - Bisphosphonates
    - Alendronate, Etidronate, Ibandronate, Pamidronate, Risedronate, Zoledronic Acid
  - Hormonal Agents
    - Calcitonin, Teriparatide
    - Selective Estrogen Receptor Modulators
      - Bazedoxifene, Raloxifene
  - Monoclonal Antibodies
    - Denosumab, Romosozumab
- Parkinson Disease Agents
  - Anticholinergic Agents
    - Benztropine, Biperiden, Trihexyphenidyl
  - COMT Inhibitors
    - Entacapone, Opicapone, Tolcapone
  - Dopamine Precursors
    - Levodopa and Carbidopa
  - Dopamine Receptor Agonists
    - Apomorphine, Bromocriptine, Pergolide, Pramipexole, Ropinirole, Rotigotine
  - Selective MAO Inhibitors
    - Rasagiline, Safinamide, Selegiline
  - Others
    - Amantadine, Diphenhydramine, Droxidopa, Istradefylline , Pimavanserin, Rivastigmine
- Penicillins, First Generation (Natural Penicillins)
  - Benzathine Penicillin, Procaine Penicillin, Penicillin G, Penicillin V, Penicillin VK
- Penicillins, Second Generation (Penicillinase-Resistant Penicillins)
  - Cloxacillin, Dicloxacillin, Flucloxacillin, Methicillin, Nafcillin, Oxacillin
- Penicillins, Third Generation (Aminopenicillins)
  - Amoxicillin, Ampicillin, Ampicillin-Sulbactam, Bacampicillin, Pivampicillin
  - See also Amoxicillin-Clavulanate
- Penicillins, Fourth Generation (Extended-Spectrum Penicillins)
  - Carbenicillin, Mezlocillin, Piperacillin, Piperacillin-Tazobactam, Ticarcillin, Ticarcillin-Clavulanate
- Pharmacokinetic Enhancers [Primary Agent]
  - Avibactam [Ceftazidime], Carbidopa [Levodopa], Cilasta, in [Imipenem], Clavulanic Acid [Amoxicillin, Ticarcillin], Cobicistat [Atazanavir, Darunavir, Elvitegravir], Ritonavir [Lopinavir, Paritaprevir], Sulbactam [Ampicillin], Tazobactam [Piperacillin], Tipiracil [Trifluridine]
- Phosphodiesterase Type 5 (PDE5) Inhibitors
  - Avanafil, Sildenafil, Tadalafil, Vardenafil
- Protein Kinase Inhibitors
  - Abemaciclib, Abrocitinib, Acalabrutinib, Adagrasib, Afatinib, Alectinib, Alpelisib, Asciminib, Avapritinib, Axitinib, Baricitinib, Belumosudil, Binimetinib, Bortezomib, Bosutinib, Brigatinib, Cabozantinib, Capivasertib, Capmatinib, Carfilzomib, Ceritinib, Cobimetinib, Copanlisib, Crizotinib, Dabrafenib, Dacomitinib, Dasatinib, Deucravacitinib, Deuruxolitinib, Duvelisib, Enasidenib, Encorafenib, Ensartinib, Entrectinib, Erdafitinib, Erlotinib, Fedratinib, Fostamatinib, Fruquintinib, Futibatinib, Gefitinib, Gilteritinib, Glasdegib, Ibrutinib, Idelalisib, Imatinib, Inavolisib, Infigratinib, Ivosidenib, Ixazomib, Lapatinib, Lazertinib, Larotrectinib, Lenvatinib, Leniolisib, Lorlatinib, Midostaurin, Mobocertinib, Momelotinib, Neratinib, Nilotinib, Niraparib, Olaparib, Olutasidenib, Osimertinib, Pacritinib, Palbociclib, Pazopanib, Pemigatinib, Repotrectinib, Revumenib, Pexidartinib, Pirtobrutinib, Ponatinib, Pralsetinib, Quizartinib, Regorafenib, Ribociclib, Ripretinib, Ritlecitinib, Rucaparib, Ruxolitinib, Selpercatinib, Selumetinib, Sonidegib, Sorafenib, Sotorasib, Sunitinib, Talazoparib, Tepotinib, Tivozanib, Tofacitinib, Tovorafenib, Trametinib, Trilaciblib, Tucatinib, Umbralisib, Upadacitinib, Vandetanib, Vemurafenib, Vismodegib, Zanubrutinib
  - See also Antineoplastic Agents; Antirheumatic Agents; Hematologic Growth Factors; Macular Degeneration Agents
- Psoriasis Agents
  - See Dermatologic Agents
- Pulmonary Disease Agents
  - Chronic Obstructive Pulmonary Disease (COPD) Agents
    - Anticholinergic Agents
      - Ipratropium, Tiotropium, Aclidinium
    - Beta-2 Adrenergic Agonists
      - Albuterol, Formoterol, Salmeterol, Terbutaline
    - Corticosteroids
      - Budesonide, Fluticasone
    - Miscellaneous
      - Roflumilast, Theophylline
  - Pulmonary Arterial Hypertension Agents
    - Endothelin Receptor Antagonists
      - Ambrisentan, Bosentan, Macitentan
    - Phosphodiesterase Type 5 (PDE5) Inhibitors
      - Avanafil, Sildenafil, Tadalafil, Vardenafil
    - Prostacyclin Analogs
      - Epoprostenol, Iloprost, Treprostinil
    - Miscellaneous
      - Riociguat, Selexipag, Vericiguat
  - Pulmonary Fibrosis Agents
    - Nintedanib, Pirfenidone
- Renal Disease Agents
  - Difelikefalin
- Rifaximin
- Salicylates
  - Aspirin, Diflunisal, Salsalate, Trisalicylate
- Sedatives and Hypnotics
  - Antihistamines
    - Diphenhydramine, Doxylamine, Hydroxyzine
  - Barbiturates
    - Amobarbital, Butabarbital, Phenobarbital, Secobarbital
  - Benzodiazepines
    - Alprazolam, Diazepam (Intravenous), Diazepam (Oral), Estazolam, Flurazepam, Quazepam, Remimazolam, Temazepam, Triazolam
  - Benzodiazepine Receptor Agonists
    - Eszopiclone, Zaleplon, Zolpidem
  - Herbals
    - Chamomile (Matricaria recutita), Hops (Humulus lupulus), Lavender (Lavandula angustifolia), Passionflower (Passiflora incarnata), Valerian (Valeriana officinalis)
  - Melatonin and its Analogues
    - Melatonin, Ramelteon, Tasimelteon
  - Orexin Receptor Antagonists
    - Daridorexant, Lemborexant, Suvorexant
  - Miscellaneous
    - Buspirone, Chloral Hydrate, Doxepin, Meprobamate, Oxybate (Narcolepsy Agent)
- Sjögren Syndrome Agents
  - Cholinergic Agents
    - Cevimeline, Pilocarpine
- Statins
  - Atorvastatin, Fluvastatin, Lovastatin, Pravastatin, Rosuvastatin, Simvastatin
- Substance Abuse Treatment Agents
  - Acamprosate, Buprenorphine, Disulfiram, Methadone, Nalmefene, Naloxegol, Naloxone, Naltrexone, Nicotine, Varenicline
- Sulfonamides
  - Dapsone, Sulfadiazine, Sulfadoxine-Pyrimethamine, Sulfamethoxazole-Trimethoprim, Sulfasalazine, Sulfinpyrazone, Sulfisoxazole
- Tamoxifen
- Tetracyclines
  - Demeclocycline, Doxycycline, Eravacycline, Minocycline, Omadacycline, Sarecycline, Tetracycline, Tigecycline
- Thalidomide
- Thyroid and Antithyroid Agents
  - Thyroid Agents
    - Thyroid Hormone, Levothyroxine, Liothyronine
  - Antithyroid Agents
    - Methimazole, Propylthiouracil; Teprotumumab (for Graves ophthalmopathy)
- Tibolone
- Trace Elements and Metals
  - Arsenic, Bismuth, Cadmium, Chromium, Copper, Fluoride, Iodine, Iron, Lead, Lithium, Manganese, Mercury, Molybdenum, Nickel, Selenium, Silicon, Tin, Vanadium, Zinc
- Transplant Agents
  - Antithymocyte Globulin
  - Cyclosporine, Everolimus, Mycophenolate, Sirolimus, Tacrolimus
  - Monoclonal Antibodies
    - Alemtuzumab, Basiliximab, Daclizumab, Muromonab
  - Plerixafor
- Tumor Necrosis Factor Antagonists
  - Adalimumab, Certolizumab, Etanercept, Golimumab, Infliximab
- Tyrosine Kinase Receptor Inhibitors
  - Axitinib, Bortezomib, Bosutinib, Carfilzomib, Crizotinib, Dabrafenib, Dasatinib, Erlotinib, Gefitinib, Ibrutinib, Imatinib, Lapatinib, Nilotinib, Pazopanib, Ponatinib, Regorafenib, Ruxolitinib, Sorafenib, Sunitinib, Tofacitinib, Trametinib, Vandetanib, Vemurafenib, Vismodegib
- Urologic Agents
  - Overactive Bladder Syndrome Agents
    - Darifenacin, Fesoterodine, Flavoxate, Hyoscyamine, Mirabegron, Oxybutynin, Solifenacin, Tolterodine, Trospium, Vibegron
- Vancomycin
- Vinca Alkaloids
  - Vinblastine, Vincristine, Vinorelbine
- Vitamins
  - Folic Acid (Folate, Folinic Acid)
  - Vitamin A & Retinoids
    - Vitamin A
    - Acitretin, Etretinate, Isotretinoin
    - Bexarotene
  - Vitamin B
    - Biotin, Choline, Cyanocobalamin, Niacin (Nicotinamide, Nicotinic Acid), Pantothenic Acid, Pyridoxine, Riboflavin, Thiamine
  - Vitamin C (Ascorbic Acid)
  - Vitamin D (Cholecalciferol, Ergocalciferol)
  - Vitamin E (alpha Tocopherol)
  - Vitamin K (Menadione, Phytonadione)
- Weight Loss Agents
  - Diethylpropion, Lorcaserin, Naltrexone-Bupropion, Orlistat, Phentermine, Phentermine-Topiramate, Setmelanotide, Sibutramine